# Diazepam (Oral)

## OVERVIEW

### Introduction

Diazepam is a benzodiazepine that is widely used orally as an anxiolytic agent and muscle relaxant. Intravenous forms of diazepam are used for acute severe agitation, as a premediation for anesthesia, a sedative for minor surgery or invasive procedures, and for treatment of status epilepticus or severe recurrent seizures. Diazepam therapy has not been associated with serum aminotransferase elevations, and clinically apparent liver injury from diazepam has been reported but is exceedingly rare.

### Background

Diazepam (dye az' e pam) is a benzodiazepine that in oral formulations is used for the therapy of anxiety, alcohol withdrawal symptoms and muscle spasms. Parenteral forms of diazepam are used for control of seizures and status epilepticus and as an adjunct to anesthesia or sedation for minor surgical procedures. The sedative activity of the benzodiazepines is mediated by their ability to enhance gamma-aminobutyric acid (GABA) mediated inhibition of synaptic transmission through binding to the GABA-A receptor. Diazepam was approved in the United States in 1963 and is still in wide use with more than 5 million prescriptions filled yearly. Diazepam is available in tablets of 2, 5 and 10 mg in generic forms and formerly under the brand name of Valium. Oral solutions and rectal gels are also available. Current indications for oral diazepam include treatment of anxiety disorders, acute alcohol withdrawal and as an adjunct to relief of skeletal muscle spasm. Among oral forms of benzodiazepines, diazepam is not as effective or well tolerated as a therapy for epilepsy as are clobazam, clonazepam and clorazepate. The typical dose of diazepam used for anxiety is 2 to 10 mg given two to four times daily. Diazepam is also available as a solution for injection, usually in vials or syringes of 5 mg/mL. Current indications for intravenous diazepam include premedication for surgery, acute agitation due to alcohol withdrawal, as an adjunct to endoscopic and minimally invasive procedures and for treatment of status epilepticus and severe recurrent seizures. Common side effects of diazepam include somnolence, dizziness, confusion, dysarthria, and diplopia. Acute overdose of diazepam can cause coma, respiratory arrest and death. Diazepam like all oral benzodiazepines has a boxed warning in its product label stressing (1) the risks of severe sedation and potentially fatal respiratory depression when combined with opiates, (2) with prolonged use, the risks of abuse, misuse, and addiction which can lead to overdose and death, and (3) with continued use, the risks of physical and psychological dependence and severe potentially life-threatening withdrawal symptoms if discontinued suddenly. Benzodiazepines are all categorized as Schedule IV controlled substances, having potential for dependence, tolerance, and abuse.

### Hepatotoxicity

Like other benzodiazepines, diazepam is rarely associated with serum ALT or alkaline phosphatase elevations during therapy. Furthermore, clinically apparent liver injury from diazepam is exceedingly rare. A small number of cases of hepatic injury have been described in patients on oral diazepam, but the clinical pattern has varied. The onset of injury has ranged from 1 to 6 months, and pattern of serum enzyme elevations has typically been cholestatic or mixed. Fever and rash are uncommon as is autoantibody formation. In large surveys and case series of clinically apparent drug induced liver injury, diazepam and other benzodiazepines are usually not listed. There have been no case reports of hepatotoxicity from diazepam since the 1980s and before the general available of tests for acute hepatitis A and C and advanced methods of hepatic and biliary imaging.

Likelihood score: D (Possible but rare cause of clinically apparent liver injury).

### Mechanism of Injury

The liver injury from benzodiazepines is probably due to a rarely produced intermediate metabolite. Diazepam is metabolized in the liver to its active metabolite which is excreted in the urine.

### Outcome and Management

The case reports of hepatic injury due to oral diazepam were followed by complete recovery, without evidence of residual or chronic injury. No cases of acute liver failure or chronic liver injury due to diazepam have been described. There is no information about cross reactivity with other benzodiazepines (clobazam, clorazepate, lorazepam or alprazolam), but some degree of cross sensitivity may occur.

Drug Class: Benzodiazepines; see also Diazepam (Intravenous)

## CASE REPORT

### Case 1. Cholestatic hepatitis due to oral diazepam.(1)

A 33 year old woman was started on diazepam (2 mg three times daily) for anxiety and four months later developed symptoms of abdominal pain and jaundice. Serum ALT was 306 U/L, alkaline phosphatase was twice elevated and bilirubin was 4.2 mg/dL. A cholecystectomy was done for suspected cholelithiasis, but the gallbladder and biliary tree were normal. A liver biopsy showed acute hepatocellular injury and cholestasis compatible with drug induced liver disease. Diazepam was stopped and she recovered rapidly and had normal liver tests one month later. Tests for hepatitis A, B and C were not available.

#### Key Points

Medication: | Diazepam (2 mg three times daily orally)
Pattern: | Mixed (R=~4)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 4 months
Recovery: | Complete recovery within a month of stopping
Other medications: | Birth control pills

#### Comment

The patient developed an acute hepatitis-like illness four months after starting diazepam. A liver biopsy showed changes typical of drug induced liver disease and the pattern of enzyme elevations and biopsy did not suggest viral hepatitis, serological testing for which was not available at the time. Causality assessment can only rank this example as a “possible” case of diazepam induced liver injury. In view of the wide scale use of diazepam, instances of hepatic injury are very rare, and no cases of severe, prolonged, persistent or fatal liver injury from diazepam have been published.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Diazepam – Generic, Valium® (Trade name discontinued)

DRUG CLASS

Benzodiazepines, Antianxiety Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Diazepam)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Diazepam | 439-14-5 | C16-H13-Cl-N2-O

## CITED REFERENCES

1 Fors B, Nilsson F. (1968). Lakartidningen.

## ANNOTATED BIBLIOGRAPHY

References updated: 22 June 2023

Zimmerman HJ. Benzodiazepines. Psychotropic and anticonvulsant agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 491-3. (Expert review of benzodiazepines and liver injury published in 1999 mentions that rare instances of cholestatic hepatitis have been reported due to alprazolam, chlordiazepoxide, diazepam, flurazepam, and triazolam, and hepatocellular injury with clorazepate and clotiazepam, but no reports of hepatic injury with lorazepam, oxazepam or temazepam).
Larrey D, Ripault MP. Benzodiazepines. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 455. (Review of benzodiazepine induced liver injury mentions that increases in liver enzymes during therapy are rare and significant hepatotoxicity uncommon, only a few cases [usually cholestatic] have been reported with alprazolam, chlordiazepoxide, diazepam, flurazepam and triazolam).
Mihic SJ, Mayfield J, Harris RA. Hypnotics and sedatives. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 339-53. (Textbook of pharmacology and therapeutics).
Cook GC, Sherlock S. (1965). Jaundice and its relation to therapeutic agents. Lancet. (11 cases of drug induced liver disease, all due to agents no longer in use; 2 were receiving diazepam, but other agents were more likely the cause).
Cunningham ML. (1965). Acute hepatic necrosis following treatment with amitriptyline and diazepam. Brit J Psychiat. (54 year old woman with dementia-depression developed progressive confusion 5 months after starting amitriptyline and diazepam, which was followed by jaundice, obtundation and death [bilirubin 5.2 mg/dL, ALT 200 U/L, Alk P 9.5 unknown units]; autopsy showed small liver, but no description of histology; role of diazepam unclear).
Buchanan N, Cane RD. (1978). Liver function tests and the prolonged use of high-dose diazepam with special reference to tetanus. S Afr Med J. (After noting jaundice in a few patients receiving high doses of diazepam for tetanus, the authors prospectively tested 4 patients finding no consistent rises in serum ALT, Alk P or bilirubin on intravenous therapy).
Stacher G. (1973). Intrahepatic cholostasis following combined diazepam-barbiturate therapy in patients with tetanus]. Wien Klin Wochenschr.
Franks E, Jacobs WH. (1975). Cholestatic jaundice possibly due to benzodiazepine-type drugs. Mo Med. (40 year old woman on multiple drugs including chlorpromazine developed jaundice [bilirubin 2.0 rising to 9.7 mg/dL, ALT 280 U/L, Alk P 546 U/L, 16% eosinophils] and seemed to worsen on benzodiazepines including chlordiazepoxide, diazepam and flurazepam, improving rapidly when they were stopped, but attribution to benzodiazepines was difficult).
Fors B, Nilsson F. (1968). Lakartidningen. (24- and 34 year old women developed mild hepatitis with jaundice 1 and 4 months after starting diazepam [bilirubin 11 and 4.2 mg/dL, ALT 434 U/L, Alk ~2 times ULN], rapid resolution with stopping: Case 1).
Tedesco FJ, Mills LR. (1982). Diazepam (Valium) hepatitis. Dig Dis Sci. (45 year old man developed elevations of ALT [130 U/L] while on isoniazid [for 1 day] and diazepam [3 days], which resolved upon stopping and recurred upon rechallenge with diazepam, but not isoniazid which was tolerated long term).
Døssing M, Andreasen PB. (1982). Drug-induced liver disease in Denmark. An analysis of 572 cases of hepatotoxicity reported to the Danish Board of Adverse Reactions to Drugs. Scand J Gastroenterol. (Among 572 cases of hepatotoxicity reported to a Danish registry between 1968 and 1978, 97 were due to psychotropic agents, but only two attributed to benzodiazepines).
Davion T, Capron-Chivrac D, Andrejak M, Capron JP. (1985). Gastroenterol Clin Biol. (Review of hepatotoxicity of anticonvulsants; among benzodiazepines, cases of cholestatic hepatitis have been linked to chlordiazepoxide and diazepam, but liver injury from this class of drugs is exceptionally rare).
Judd FK, Norman TR, Marriott PF, Burrows GD. (1986). A case of alprazolam-related hepatitis. Am J Psychiatry. (59 year old woman developed lethargy 2 weeks after starting alprazolam followed by jaundice [bilirubin 2.6 mg/dL, AST 156 U/L, Alk P 241 U/L], resolving within 4 weeks of switching to diazepam).
Nahata MC, Murray RD, Zingarelli J, Li BU, McClung HJ, Lininger B. (1990). Efficacy and safety of a diazepam and meperidine combination for pediatric gastrointestinal procedures. J Pediatr Gastroenterol Nutr. (Prospective study of safety of intravenous diazepam in 30 children undergoing endoscopy; no mention of ALT abnormalities or liver injury).
Wallace SJ. (1996). A comparative review of the adverse effects of anticonvulsants in children with epilepsy. Drug Saf. (Systematic review; ALT elevations occur in 4% of children on phenytoin, 6% on valproate, 1% on carbamazepine; “No child taking… benzodiazepines had raised liver enzyme levels,”).
Lewis JH, Zimmerman HJ. (1999). Drug- and chemical-induced cholestasis. Clin Liver Dis. (Review of drug induced cholestatic syndromes, listing many causes including chlordiazepoxide and flurazepam; “Benzodiazepines may cause cholestatic injury, although this is rare”).
Selim K, Kaplowitz N. (1999). Hepatotoxicity of psychotropic drugs. Hepatology. (Review of hepatotoxicity of phenothiazines, butyrophenones, tricyclics, MAO inhibitors, acetylcholinesterase inhibitors, and psychotropic drugs of abuse; “benzodiazepines…have a very low hepatotoxic potential, with only case reports in the literature, usually with a cholestatic pattern”).
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. (2007). Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther. (Among 126 cases of drug induced liver injury seen in Spain between 1993-2000, 20 were attributed to benzodiazepines including 5 for clorazepate, 5 alprazolam, 6 lorazepam and 4 diazepam, but compared to controls, the relative risk of injury was increased only for clorazepate [8.3: estimated frequency 3.4 per 100,000 person-year exposures]).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, none were attributed to a benzodiazepine).
Björnsson E. (2008). Hepatotoxicity associated with antiepileptic drugs. Acta Neurol Scand. (Review of hepatotoxicity of all anticonvulsants focusing upon phenytoin, valproate, carbamazepine; “Furthermore, hepatoxicity has not been convincingly shown to be associated with the use of benzodiazepines”).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to a benzodiazepine).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population-based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to a benzodiazepine, despite the fact that millions of prescriptions are filled yearly).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature on drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to diazepam or any other benzodiazepine).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to diazepam or any other benzodiazepine).
Carvalhana S, Oliveira A, Ferreira P, Resende M, Perdigoto R, Barroso E. (2017). Acute liver failure due to trazodone and diazepam. GE Port J Gastroenterol. (63 year old man developed acute liver failure 3 months after starting trazodone and diazepam [bilirubin 12.0 mg/dL, ALT 4638 U/L, Alk P 122 U/L, INR 1.84], with worsening liver failure and transplant two weeks later).
Lugoboni F, Mirijello A, Morbioli L, Arzenton E, Leone R, Faccini M, Casari R, et al. (2018). Does high-dose benzodiazepine abuse really produce liver toxicity? Results from a series of 201 benzodiazepine monoabusers. Expert Opin Drug Saf. (Among 201 patients see for benzodiazepine abuse, 10% had elevations in liver enzymes, but none were suggestive of drug induced liver injury, and most were associated with overweight or obesity).
(2019). Drugs for anxiety disorders. Med Lett Drugs Ther. (Concise review of drugs for anxiety including benzodiazepines summaries their mechanism of action, clinical efficacy, safety, and costs; mentions that benzodiazepines such as diazepam can provide immediate relief of anxiety symptoms, but long term therapy can cause tolerance and dependence, and sudden withdrawal can cause severe and even life-threatening symptoms; no mention of ALT elevations or hepatotoxicity).
Kamitaki BK, Minacapelli CD, Zhang P, Wachuku C, Gupta K, Catalano C, Rustgi V. (2021). Drug-induced liver injury associated with antiseizure medications from the FDA Adverse Event Reporting System (FAERS). Epilepsy Behav. (Analysis of 112,901 spontaneous adverse event reports of antiseizure medications to the FDA, 2175 of which [4.8%] were for liver injury including 1232 hospitalizations and 262 deaths, the reporting odds ratio for liver injury being high [>2.0] for carbamazepine, phenobarbital, phenytoin, valproate, oxcarbazepine, and lamotrigine and modestly elevated [1.0-2.0] for clobazam, diazepam, and levetiracetam, but not elevated [<1.0] for gabapentin, topiramate, clonazepam and zonisamide).

## OTHER REFERENCE LINKS

1 Recent References on Diazepam: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Diazepam/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Diazepam: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Diazepam)